# Fluvoxamine

## OVERVIEW

### Introduction

Fluvoxamine is a selective serotonin reuptake inhibitor (SSRI) used in the therapy of obsessive-compulsive disorder. Fluvoxamine therapy can be associated with transient asymptomatic elevations in serum aminotransferase levels and has been linked to rare instances of clinically apparent acute liver injury.

### Background

Fluvoxamine (floo vox' a meen) is a selective serotonin reuptake inhibitor (SSRI) that was developed largely for use in obsessive-compulsive disorder. Fluvoxamine acts by blocking the reuptake of serotonin in CNS synaptic clefts, thus increasing serotonin levels in the brain which is associated with its psychiatric effects. Fluvoxamine was approved for use in obsessive-compulsive disorder in 1994 in the United States and is used in both adults and children above the age of 8 years. It is also used for social anxiety disorder, but not specifically for depression or bipolar disorders. Fluvoxamine is available as tablets of 25, 50 and 100 mg in multiple generic forms and under the brand name of Luvox. Extended release forms are also available in doses of 100 and 150 mg. The recommended dosage in adults is 50 mg once daily, increasing to a maximum of 300 mg. The dosage in children is 25 mg daily, increasing to a maximum of 200 to 300 mg based upon age below or above 11 years. Common side effects are drowsiness, dyspepsia, nausea, headache, increased sweating, increased appetite, weight gain and sexual dysfunction.

Fluvoxamine is also a potent sigma-1 receptor (S1R) agonist, which results in an inhibition of proflammatory cytokine production. Because the proinflammatory cytokines such as IL-6 play a role in the hyperinflammatory response in severe COVID-19 pneumonia, fluvoxamine has been proposed as a therapy for COVID-19. Several small case series and clinical trials have suggested that fluvoxamine may prevent clinical deterioration in patients with SARS-CoV-2 infection, particularly if used before the onset of respiratory failure and the full scale hyperinflammatory state. Clinical trials of the efficacy or safety of fluvoxamine are currently underway.

### Hepatotoxicity

Liver test abnormalities have been reported to occur in up to 1% patients on fluvoxamine, but elevations are usually modest and usually do not require dose modification or discontinuation. A few instances of acute, clinically apparent episodes of liver injury with marked liver enzyme elevations with no or minimal jaundice have been reported in patients on fluvoxamine. The onset of injury was within a few days of starting therapy and the pattern of serum enzyme elevations was hepatocellular or mixed. Autoimmune (autoantibodies) and immunoallergic features (rash, fever, eosinophilia) were not mentioned. Too few cases have been reported to characterize the clinical features of the liver injury in any detail. In large scale analyses of hepatic adverse events due to antidepressants and SSRIs, fluvoxamine is rarely mentioned.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which fluvoxamine causes liver injury is not known. Fluvoxamine is extensively metabolized by the liver, mainly via the cytochrome P450 system, and hepatotoxicity may be mediated by toxic intermediates of their metabolism. In addition, fluvoxamine inhibits several CYP enzymes and has significant drug-drug interactions.

### Outcome and Management

The serum aminotransferase elevations that occur on fluvoxamine therapy are usually self-limited and do not require dose modification or discontinuation of therapy. No instances of acute liver failure or chronic liver injury have been attributed to fluvoxamine therapy. Restarting fluvoxamine has been reported to cause a rapid recurrence of injury and should be avoided. Persons with intolerance to fluvoxamine may have similar reactions to other SSRIs, and careful monitoring is warranted if other such agents are used.

Drug Class: Antidepressant Agents, COVID-19 Drugs

Other Drugs in the Subclass, SNRIs/SSRIs: Citalopram, Escitalopram, Duloxetine, Fluoxetine, Levomilnacipran, Paroxetine, Sertraline, Venlafaxine, Vilazodone, Vortioxetine

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Fluvoxamine – Generic, Luvox®

DRUG CLASS

Antidepressant Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=fluvoxamine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Fluvoxamine | 54739-18-3 | C15-H21-F3-N2-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 11 May 2021

Zimmerman HJ. Tricyclic antidepressants. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 493-8. (Expert review of hepatotoxicity published in 1999 discusses several antidepressants including SSRIs but not fluvoxamine).
Larrey D, Ripault MP. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 443-62. (Review of hepatotoxicity of antidepressants mentions that clinically apparent liver injury from fluvoxamine is rare and the clinical picture is usually hepatocellular).
O'Donnell JM, Shelton RC. Drug therapy for depression and anxiety disorders. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 397-416. (Textbook of pharmacology and therapeutics).
Lam KS, Blanchi A, Chavaillon JM. (1988). Gastroenterol Clin Biol. (63 year old woman took an overdose of fluvoxamine [~1500 mg] and within 24 hours had elevations in ALT [1059 U/L], Alk P [668 U/L] and bilirubin [1.4 mg/dL], which remained high for more than a month).
Mourilhe P, Stokes PE. (1998). Risks and benefits of selective serotonin reuptake inhibitors in the treatment of depression. Drug Saf. (Review of pharmacology, efficacy and safety of SSRIs; no mention of ALT elevations or hepatotoxicity).
Grohmann R, Rüther E, Engel RR, Hippius H. (1999). Assessment of adverse drug reactions in psychiatric inpatients with the AMSP drug safety program: methods and first results for tricyclic antidepressants and SSRI. Pharmacopsychiatry. (Analysis of reporting of adverse events among inpatients in 29 German hospitals between 1993 to 1997; 896 severe adverse events were reported among 48,564 patients [1.8%], both total and hepatic events were more common with tricyclics than SSRIs).
Carvajal García-Pando A, García del Pozo J, Sánchez AS, Velasco MA, Rueda de Castro AM, Lucena MI. (2002). Hepatotoxicity associated with the new antidepressants. J Clin Psychiatry. (Analysis of cases of hepatotoxicity from antidepressants in Spanish Pharmacovigilance System from 1989-1999, identified 99 cases; among SSRIs, 26 were due to fluoxetine, 14 paroxetine, 6 fluvoxamine, 5 sertraline, 3 venlafaxine and 2 citalopram; among tricyclics, 16 clomipramine 7 amitriptyline, 6 imipramine; among miscellaneous, 3 nefazodone and 1 trazodone; but all similar in rate of occurrence estimated to be 1-3 per 100,000 patient-years of exposure, except for nefazodone=29/100,000).
Lucena MI, Carvajal A, Andrade R, Velasco A. (2003). Antidepressant-induced hepatotoxicity. Expert Opin Drug Saf. (Review of hepatotoxicity of antidepressants; antidepressant use has increased markedly between 1992 and 2002, accounting for 5% of cases of hepatotoxicity; SSRIs are less likely to cause injury than tricyclics and MAO inhibitors; range of presentations, typically self-limited and rapid recovery; no hallmarks of hypersensitivity).
Spigset O, Hägg S, Bate A. (2003). Hepatic injury and pancreatitis during treatment with serotonin reuptake inhibitors: data from the World Health Organization (WHO) database of adverse drug reactions. Int Clin Psychopharmacol. (Among 27,542 reports of hepatic injury in WHO database, 786 were related to SSRIs [3%], including citalopram 42, fluoxetine 222, fluvoxamine 54, paroxetine 191, sertraline 112, nefazodone 91 and venlafaxine 74; only nefazodone had an excess of hepatic reports in relationship to total reports).
Degner D, Grohmann R, Kropp S, Rüther E, Bender S, Engel RR, Schmidt LG. (2004). Severe adverse drug reactions of antidepressants: results of the German multicenter drug surveillance program AMSP. Pharmacopsychiatry. (Analysis of adverse drug reactions reported from 1993-2000 in 35 psychiatric hospitals; 0.7% of SSRI recipients had a severe adverse event; hepatic in 0.05%).
Solomons K, Gooch S, Wong A. (2005). Toxicity with selective serotonin reuptake inhibitors. Am J Psychiatry. (38 year old woman developed abdominal pain and ALT elevations [378 U/L] without jaundice 9 days after starting fluvoxamine; had a positive rechallenge and recurrence with citalopram [ALT 379 within 4 days], and positive rechallenge with citalopram again 1 year later).
Pinzani V, Peyrière H, Hillaire-Buys D, Pageaux GP, Blayac BP, Larrey D. (2006). Specific serotonin recapture inhibitor (SSRI) antidepressants: hepatoxicity assessment in a large cohort in France. J Hepatol. (Abstract; analysis of French Pharmacovigilance data on SSRIs found 63 cases of hepatotoxicity from paroxetine, 45 fluoxetine, 30 citalopram, 18 sertraline, and 2 fluvoxamine).
Sabaté M, Ibáñez L, Pérez E, Vidal X, Buti M, Xiol X, Mas A, et al. (2007). Risk of acute liver injury associated with the use of drugs: a multicentre population survey. Aliment Pharmacol Ther. (Among 126 cases of drug induced liver injury seen in Spain between 1993-2000, 3 were attributed to paroxetine and 3 to fluoxetine with a relative risk of injury to rate of use in the population of 3.0 and 1.8, respectively).
DeSanty KP, Amabile CM. (2007). Antidepressant-induced liver injury. Ann Pharmacother. (Review of drug induced liver injury and reports of injury from MAO inhibitors, SSRIs, tricyclics and atypical agents).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, 6 were attributed to duloxetine, 3 to atomoxetine, 2 to fluoxetine, 2 to bupropion, and 1 to sertraline as single agents; no case attributed to fluvoxamine).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, including 1 due to fluoxetine and 1 to venalaxine but none to fluvoxamine).
Molleston JP, Fontana RJ, Lopez MJ, Kleiner DE, Gu J, Chalasani N. (2011). Drug-induced Liver Injury Network. Characteristics of idiosyncratic drug-induced liver injury in children: results from the DILIN prospective study. J Pediatr Gastroenterol Nutr. (Among 30 children with suspected drug induced liver injury, half [n=15] were due to antimicrobials [minocycline 4, INH 3, azithromycin 3] and the rest largely due to CNS agents and anticonvulsants; one case was attributed to amitriptyline, but no other antidepressant was listed).
Park SH, Ishino R. (2013). Liver injury associated with antidepressants. Curr Drug Saf. (Review of antidepressant induced liver injury).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, none of which were attributed to fluvoxamine or other SSRIs, despite the fact that 5 SSRIs ranked among the top 30 most frequently prescribed drugs in Iceland).
Voican CS, Corruble E, Naveau S, Perlemuter G. (2014). Antidepressant-induced liver injury: a review for clinicians. Am J Psychiatry. (Review of antidepressant induced liver injury mentions a single, anicteric case of liver injury attributed to fluvoxamine [Solomons 2005]).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, but none were attributed to fluvoxamine).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 20 cases [2%] were attributed to antidepressants, but none to fluvoxamine).
Bunchorntavakul C, Reddy KR. (2017). Drug hepatotoxicity: newer agents. Clin Liver Dis. (Review of newly approved agents that have been linked to liver injury, mentions that fluvoxamine has a lower risk of hepatotoxicity than tricyclic or SNRIs and that it has not been linked to cases of acute liver failure).
Friedrich ME, Akimova E, Huf W, Konstantinidis A, Papageorgiou K, Winkler D, Toto S, et al. (2016). Drug-induced liver injury during antidepressant treatment: results of AMSP, a drug surveillance program. Int J Neuropsychopharmacol. (Monitoring of 184,234 inpatients in 80 psychiatric hospitals for liver injury during antidepressant treatment identified 149 cases including 2 among 3991 fluvoxamine treated subjects [0.05%], a rate similar to other SSRIs and SNRIs; no cases resulted in acute liver failure or death from liver disease).
Ferrajolo C, Scavone C, Donati M, Bortolami O, Stoppa G, Motola D, Vannacci A, et al., DILI-IT Study Group. (2018). Antidepressant-induced acute liver injury: a case-control study in an Italian inpatient population. Drug Saf. (Among 179 cases of hospitalizations for unexplained acute liver injury enrolled in a prospective study between 2010 and 2014, 17 had been exposed to antidepressants, but none specifically to fluvoxamine).
Billioti de Gage S, Collin C, Le-Tri T, Pariente A, Bégaud B, Verdoux H, Dray-Spira R, et al. (2018). Antidepressants and hepatotoxicity: a cohort study among 5 million individuals registered in the French National Health Insurance Database. CNS Drugs. (Among 5 million persons identified in a national French health insurance database who started an antidepressant between 2010 and 2015, 382 developed serious liver injury resulting in hospitalization, rates per 100,0000 persons-years being 19 for SSRIs, 22 venlafaxine, 13 duloxetine, and 33 mirtazapine).
Chan HL, Chiu WC, Chen VC, Huang KY, Wang TN, Lee Y, McIntyre RS, et al. (2018). SSRIs associated with decreased risk of hepatocellular carcinoma: A population-based case-control study. Psychooncology. (Analysis of the Taiwan National Health Service Insurance Research Database identified 59,859 patients with initial diagnosis of hepatocellular carcinoma and 285,124 matched controls; SSRI [including fluvoxamine] use was more frequent in the controls than in the HCC cases, but only in analyses adjusted for possibly confounding factors).
(2020). Drugs for depression. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and costs of drugs for depression; hepatotoxicity is mentioned only for nefazodone [now rarely used because of severe hepatotoxicity] and duloxetine [in heavy drinkers]; most SSRIs but not fluvoxamine are discussed).
Ueberberg B, Frommberger U, Messer T, Zwanzger P, Kuhn J, Anghelescu I, Ackermann K, Assion HJ. (2020). Drug-induced liver injury (DILI) in patients with depression treated with antidepressants: a retrospective multicenter study. Pharmacopsychiatry. (Among 329 psychiatric inpatients with depression seen at 6 psychiatric centers in Germany, 17 [5%] had serum aminotransferase elevations but none had clinically apparent liver injury, most commonly implicated drugs included mirtazapine, agomelatine, citalopram and venlafaxine; fluvoxamine is not mentioned).
Lenze EJ, Mattar C, Zorumski CF, Stevens A, Schweiger J, Nicol GE, Miller JP, et al. (2020). Fluvoxamine vs placebo and clinical deterioration in outpatients with symptomatic COVID-19: a randomized clinical trial. JAMA. (Among 152 non-hospitalized patients with early SARS-CoV-2 infection, clinical deterioration arose in 8.3% [6 of 72] treated with placebo vs none [0 of 80] treated with fluvoxamine [100 mg three times daily for 14 days], an SSRI that also is a potent sigma-1 receptor agonist; adverse events were more frequent among placebo recipients, 4 of who required hospitalization and one mechanical ventilation vs none receiving fluvoxamine).
Anderson GM. (2021). Fluvoxamine, melatonin and COVID-19. Psychopharmacology (Berl). (Review of fluvoxamine and melatonin as potential therapies for COVID-19 mentions that fluvoxamine, besides inhibiting the sigma-1 receptor also inhibits CYP 1A2 and 2C19, effects that decrease the metabolism of melatonin can result in increased serum levels).
Seftel D, Boulware DR. Prospective cohort of fluvoxamine for early treatment of coronavirus disease 19. Open Forum Infect Dis 2021; 8: ofab050. (Among patients testing positive for SARS-CoV-2 who were offered therapy with fluvoxamine [loading dose followed by 50 mg twice daily for 14 days], 65 agreed among whom none developed symptoms as of day 14 and none were hospitalized compared to 48 who refused treatment among whom 29 developed symptoms, 6 were hospitalized and 1 died).
Sukhatme VP, Reiersen AM, Vayttaden SJ, Sukhatme VV. (2021). Fluvoxamine: a review of Its mechanism of action and its role in COVID-19. Front Pharmacol. (Review of the intracellular actions of fluvoxamine that might play a role in therapy for COVID-19 including its effects on increasing sigma-1 receptor signaling, lysosomal effects blocking viral release, antiinflammatory effects of reduction in platelet aggregation and mast cell degranulation, and drug-interaction effects in delaying metabolism of melatonin).
(2021). Fluvoxamine for COVID-19?. Med Lett Drugs Ther. (Concise review of the mechanism of action, evidence for clinical efficacy, safety and costs of fluvoxamine which is an unapproved therapy for COVID-19 that is now undergoing rigorous evaluation in randomized, placebo controlled trials).

## OTHER REFERENCE LINKS

1 Recent References on Fluvoxamine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(fluvoxamine)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Fluvoxamine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=fluvoxamine)